# Rucaparib

## OVERVIEW

### Introduction

Rucaparib is a small molecule inhibitor of poly ADP-ribose polymerase that is used in the therapy of selected patients with refractory and advanced ovarian carcinoma. Rucaparib therapy is associated with a moderate rate of transient elevations in serum aminotransferase during therapy, but has not been linked to instances of clinically apparent liver injury.

### Background

Rucaparib (roo kap' a rib) is an orally available, small molecule inhibitor of poly adenine diphosphate (ADP)-ribose polymerase (PARP), an enzyme involved in DNA transcription and repair. Patients with mutations of the BRCA 1 and 2 genes are at increased risk for cancer, particularly ovarian and breast cancer in women. The BRCA gene encodes DNA repair enzymes, and tumor cells with BRCA mutations are dependent upon other pathways of DNA repair and thus have increased sensitivity to inhibition of PARP. Clinical trials of rucaparib in women with BRCA 1 and 2 germline mutations and advanced, refractory ovarian carcinoma have shown response rates of 30% to 40% and prolongation of progression free survival. Rucaparib is also under evaluation as therapy for advanced breast cancer and other malignant diseases associated mutations in BRCA or other DNA repair enzymes. Rucaparib received approval for use in the United States in 2016 for therapy of advanced and refractory ovarian carcinoma in women with deleterious BRAC mutations. Rucaparib is available in 200 and 300 mg tablets under the brand name Rubraca. The recommended dose is 600 mg by mouth twice daily continued until disease progression or unacceptable toxicity occurs. Common side effects include anemia, fatigue, nausea, diarrhea, constipation, dyspepsia, abdominal pain, anorexia, shortness of breath and thrombocytopenia. Uncommon, but potentially severe side effects include myelodysplastic syndrome and embryo-fetal toxicity.

### Hepatotoxicity

In large clinical trials of rucaparib, abnormalities in routine liver tests were common; serum ALT elevations arising in 74% with values above 5 times the upper limit of normal (ULN) in 13%. Despite the frequency of serum enzyme elevations during therapy in clinical trials, there were no reports of hepatitis with jaundice or liver failure. Subsequent to its approval and more wide scale use, there have been no published reports of clinically apparent liver injury attributed to rucaparib. Thus, rucaparib is a frequent cause of serum enzyme elevations, but has not been linked to significant hepatotoxicity.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of injury accounting for the frequent serum enzyme elevations during rucaparib therapy is not known. Rucaparib is metabolized in the liver largely through the CYP 2D6 pathway and to a lesser extent by CYP1A2 and 3A4. Drug-drug interactions have not been described with rucaparib, but have not been systematically studied in humans.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation. There does not appear to be cross reactivity in risk for hepatic injury between rucaparib and other PARP inhibitors such as olaparib.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other PARP Drugs: Niraparib, Olaparib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Rucaparib – Rubraca®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Rucaparib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Rucaparib | 283173-50-2 | Not available | Rucaparib structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 June 2017

Abbreviations: PARP, poly adenine diphosphate ribose polymerase

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of protein kinase or PARP inhibitors such as olaparib and rucaparib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not olaparib or rucaparib).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Garnett MJ, Edelman EJ, Heidorn SJ, Greenman CD, Dastur A, Lau KW, Greninger P, et al. Systematic identification of genomic markers of drug sensitivity in cancer cells. Nature 2012; 483 (7391): 570-5. (Correlation of mutated cancer genes identified in cancer cell lines with their sensitivity to growth inhibition by antineoplastic agents revealed the possible role of PARP inhibition in several tumors including Ewing sarcoma). 22460902
Plummer R, Lorigan P, Steven N, Scott L, Middleton MR, Wilson RH, Mulligan E, et al. A phase II study of the potent PARP inhibitor, Rucaparib (PF-01367338, AG014699), with temozolomide in patients with metastatic melanoma demonstrating evidence of chemopotentiation. Cancer Chemother Pharmacol 2013; 71: 1191-9. (Among 46 patients with metastatic melanoma treated with the combination of temozolomide and rucaparib [12 mg/m^2^ intravenously for 5 days of 28-day cycles], found objective response rates of 17%; side effects including myelosuppression were common and one patient died of "hepatorenal failure"). 23423489
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013, discusses imatinib and sunitinib, but not olaparib or rucaparib). 23620168
Ledford H. Resurrected cancer drug faces regulators. Nature 2014; 510 (7506): 454. (News report on olaparib, the initial PARP inhibitor, which in early clinical trials showed little effect on survival in women with ovarian carcinoma, but on reassessment limiting analysis of cases with BRCA mutations found evidence of an effect on cancer growth, reviving interest in pursuing olaparib as therapy of selected patients with ovarian cancer). 24965630
Bao Z, Cao C, Geng X, Tian B, Wu Y, Zhang C, Chen Z, et al. Effectiveness and safety of poly (ADP-ribose) polymerase inhibitors in cancer therapy: A systematic review and meta-analysis. Oncotarget 2016; 7: 7629-39 (Systematic review of the efficacy and safety of PARP inhibitors in cancer chemotherapy; mentioned that in 5 placebo controlled trials, ALT elevations were no more frequent with the PARP inhibitors than in "controls", but neither were any other adverse events). 26399274
Konecny GE, Kristeleit RS. PARP inhibitors for BRCA1/2-mutated and sporadic ovarian cancer: current practice and future directions. Br J Cancer 2016; 115: 1157-73. (Review of role of BRCA 1 and 2 mutations in tumorigenesis and the mechanism of action of PARP inhibitors). 27736844
Ledermann JA. PARP inhibitors in ovarian cancer. Ann Oncol 2016; 27 Suppl 1: i40-i44. (Review of possible role of PARP inhibitors in ovarian cancer; mentions that cells with defective BRCA proteins are deficient in repair of double-stranded breaks in DNA by homologous recombination and rely on other pathways, notably PARP that detects single DNA strand breaks and activates effector proteins to initiate repair). 27141070
Drew Y, Ledermann J, Hall G, Rea D, Glasspool R, Highley M, Jayson G, et al. Phase 2 multicentre trial investigating intermittent and continuous dosing schedules of the poly (ADP-ribose) polymerase inhibitor rucaparib in germline BRCA mutation carriers with advanced ovarian and breast cancer. Br J Cancer 2016; 114: 723-30. (Among 78 patients with BRCA 1 or 2 mutations and advanced ovarian or breast cancer treated with rucaparib, the objective response rate was 7% and adverse events were common but usually manageable; no mention of ALT elevations or hepatotoxicity). 27002934
Wilson RH, Evans TJ, Middleton MR, Molife LR, Spicer J, Dieras V, Roxburgh P, et al. A phase I study of intravenous and oral rucaparib in combination with chemotherapy in patients with advanced solid tumours. Br J Cancer 2017; 116 (7): 884-92. (Among 85 patients with advanced cancers treated with various chemotherapy regimens and rucaparib, 10 had at least a partial response and adverse events were common including fatigue, nausea, constipation and anemia; no mention of ALT elevations or hepatotoxicity). 28222073
Swisher EM, Lin KK, Oza AM, Scott CL, Giordano H, Sun J, Konecny GE, et al. Rucaparib in relapsed, platinum-sensitive high-grade ovarian carcinoma (ARIEL2 Part 1): an international, multicentre, open-label, phase 2 trial. Lancet Oncol 2017; 18: 75-87. (Among 204 patients with relapsed, platinum-sensitive ovarian cancer treated with rucaparib [600 mg twice daily], the median progression free survival was longer in those with BRCA mutations [12.8 months] than in those with other tumor mutations [5.7 and 5.2 months], while common side effects included ALT or AST elevations in 43% of patients that were above 5 times ULN in 12%, although there were no treatment related deaths). 27908594

## OTHER REFERENCE LINKS

1. Recent References on Rucaparib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Rucaparib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Rucaparib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Rucaparib)